# Indinavir

## OVERVIEW

### Introduction

Indinavir is an antiretroviral protease inhibitor used in the therapy and prevention of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndrome (AIDS). Indinavir can cause transient and usually asymptomatic elevations in serum aminotransferase levels and mild elevations in indirect bilirubin concentration. Indinavir is a rare cause of clinically apparent, acute liver injury. In HBV or HCV coinfected patients, antiretroviral therapy with indinavir may result in an exacerbation of the underlying chronic hepatitis B or C.

### Background

Indinavir (in din' a vir) is an antiretroviral protease inhibitor that acts by binding to the catalytic site of the HIV protease, thereby preventing the cleavage of viral polyprotein precursors into mature, functional proteins that are necessary for viral replication. Indinavir was approved for use in the United States in 1996 and continues to be commonly used in combination with other antiretroviral agents for the treatment of HIV infection. Indinavir is available under the brand name Crixivan in capsules of 100, 200 and 400 mg. Indinavir is typically used in combination with a low dose of ritonavir, which improves its pharmacokinetics. The recommended dosage of indinavir is 800 mg orally every 8 hours with or without ritonavir (usually 100 to 200 mg twice daily). Side effects can include gastrointestinal upset, nausea, diarrhea, back pain, fatigue and, with long term use, hyperlipidemia and lipodystrophy.

### Hepatotoxicity

Some degree of serum aminotransferase elevations occur in a high proportion of patients taking indinavir containing antiretroviral regimens. Moderate-to severe elevations in serum aminotransferase levels (>5 times the upper limit of normal) are found in 3% to 10% of patients, although rates may be higher in patients with HIV-HCV coinfection. These elevations are usually asymptomatic and self-limited and can resolve even with continuation of the medication. Indinavir therapy also causes increases in unconjugated (indirect) and total serum bilirubin that can manifest as jaundice in up to 10% of patients. These elevations are due to the inhibition of UDP glucuronyl transferase, the hepatic enzyme responsible for conjugation of bilirubin that is deficient in Gilbert syndrome. The hyperbilirubinemia is usually mild, the increases averaging 0.3-0.5 mg/dL, but can be more marked in patients with Gilbert syndrome with increases of 1.5 mg/dL or more and clinical jaundice. The jaundice, however, is not indicative of hepatic injury. Clinically apparent acute liver injury due to indinavir is rare. The few cases that have been reported have arisen after 1 to 8 weeks of starting indinavir, and the pattern of serum enzyme elevations has varied from hepatocellular to cholestatic. Signs of hypersensitivity (fever, rash, eosinophilia) are rare as is autoantibody formation. The acute liver injury due to indinavir is usually self-limited, but it can be severe, and isolated cases of acute liver failure have been reported. In addition, initiation of indinavir based highly active antiretroviral therapy can lead to exacerbation of an underlying chronic hepatitis B or C in coinfected individuals, typically arising 2 to 12 months after starting therapy and associated with a hepatocellular pattern of serum enzyme elevations and increases in serum levels of hepatitis B virus (HBV) DNA or hepatitis C virus (HCV) RNA. Indinavir therapy has not been clearly linked to lactic acidosis and acute fatty liver that is reported in association with several nucleoside analogue reverse transcriptase inhibitors.

Likelihood score: C (frequent cause of serum bilirubin elevations and probable cause of rare instances of clinically apparent liver injury).

### Mechanism of Injury

The cause of the clinical hepatotoxicity from indinavir is only partially known. The indirect hyperbilirubinemia associated with indinavir use is caused by inhibition of hepatic conjugation of bilirubin, similar to what occurs in Gilbert syndrome and is not indicative of liver injury. Indinavir is extensively metabolized by the liver, largely by the cytochrome P450 system (CYP3A4), and toxic intermediates may be the cause of some liver injury. In patients with HIV infection who are coinfected with either HBV or HCV, initiation of potent antiretroviral therapy may be associated with flares of the underlying chronic hepatitis, which may be the result of reconstitution of the immune system, viral interactions or a direct effect of the drug.

### Outcome and Management

The severity of the liver injury from indinavir ranges from mild and transient enzyme elevations to more marked and symptomatic liver test abnormalities and, rarely, to acute hepatitis. Hepatic injury from indinavir is usually self-limited, but instances of acute liver failure and death have been reported. In the typical case, improvement starts within a few days of stopping therapy and recovery is rapid. Rechallenge may lead to recurrence and should be avoided. There is little evidence for cross reactivity to the hepatotoxicity of indinavir with other HIV protease inhibitors or antiretroviral agents. The exacerbation of hepatitis B or C that can occur with indinavir based antiretroviral therapies can be severe and lead to acute liver failure or progressive, end stage liver disease. Patients with HCV or HBV coinfection should be monitored prospectively for viral and serum aminotransferase levels and appropriate therapy instituted if possible.

References to indinavir are included with references to all the HIV protease inhibitors in the overview section of Protease Inhibitors (updated September 2017). Most of the HIV protease inhibitors in clinical use are proteinomimetic drugs and are structurally unrelated.

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Protease Inhibitors: Amprenavir, Atazanavir, Darunavir, Fosamprenavir, Lopinavir, Nelfinavir, Ritonavir, Saquinavir, Tipranavir

## CASE REPORTS

### Case 1. Indinavir induced acute hepatitis.

[Modified from: Vergis E, Paterson DL, Singh N. Indinavir-associated hepatitis in patients with advanced HIV infection. Int J STD AIDS 1998; 9:53. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9518018)]

A 46 year old man with HIV infection and AIDS (CD4 count 10 cells/µL) developed abdominal pain and nausea followed by jaundice 7 weeks after the addition of indinavir (800 mg three times daily) to a chronic antiretroviral regimen of zidovudine and didanosine. His serum enzymes were known to be normal one month before starting indinavir. His other medications included trimethoprim-sulfamethoxazole and desipramine which he had taken for at least 7 months. Serum bilirubin was 3.7 mg/dL, ALT 123 U/L, and alkaline phosphatase 136 U/L. Tests hepatitis B and C were negative. An ultrasound and CT scan of the abdomen revealed hepatomegaly, but no evidence of biliary obstruction. His antiretroviral medications were discontinued. A liver biopsy showed steatosis, eosinophilic degeneration, and fibrosis. Over the ensuing several days, the patient developed prolongation of the prothrombin time, massive ascites and anasarca requiring diuretics. His serum bilirubin peaked at 12.2 mg/dL before gradually returning to normal. Course of events and time to resolution were not provided.

#### Key Points

Medication: | Indinavir (800 mg every 8 hours)
Pattern: | Mixed, modest enzyme elevations (R=2.9)
Severity: | 4+ (evidence of hepatic failure with ascites and coagulopathy)
Latency: | 46 days
Recovery: | Yes, time not given
Other medications: | Trimethoprim-sulfamethoxazole, zidovudine, didanosine, and desipramine

#### Comment

An example of possible acute idiosyncratic hepatocellular injury with onset after 7 weeks of starting indinavir, a severe course and protracted recovery. The possible role of zidovudine and didanosine cannot be excluded, particularly in view of the presentation with ascites and anasarca and the presence of steatosis on liver biopsy. Typically, attempts at reintroduction of the agents believed to be least likely the cause of the injury can help to define which drug was responsible.

### Case 2. Fulminant hepatic failure after indinavir.

[Modified from: Bräu N, Leaf HL, Wieczorek RL, Margolis DM. Severe hepatitis in three AIDS patients treated with indinavir. Lancet 1997; 349: 924-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/9093260)]

A 48 year old man with HIV-HBV infection developed abdominal pain and jaundice 10 days after indinavir (800 mg every 8 hours) was added to his zidovudine monotherapy, which he had been on for several years. He was known to have hepatitis B surface antigen (HBsAg) in serum, but had normal serum aminotransferase levels and no signs of chronic liver disease. Before starting indinavir his CD4 count was 11 cells/µL. He was also taking trimethoprim-sulfamethoxazole and fluconazole as prophylaxis, and doxepin and nortriptyline for chronic anxiety and depression. On presentation, physical examination was normal except for jaundice. His serum aminotransferase levels, which had been normal before starting indinavir, were markedly elevated and serum bilirubin 12.5 mg/dL (Table). Tests for hepatitis A and C were negative. Computed tomography of the abdomen was normal. A liver biopsy showed moderate microvesicular fat accumulation with marked fibrosis, and inflammatory infiltrates with eosinophils. Immunostains for HBsAg and HBcAg were positive. Lactate levels and HBV DNA levels were not provided. The findings were thought to be consistent with drug induced steatohepatitis in a cirrhotic liver. Despite withdrawal of all medication, the patient’s liver disease worsened with progressive coagulopathy, hyperbilirubinaemia, ascites, and hepatorenal syndrome. He died 25 days after admission.

#### Key Points

Medication: | Indinavir (800 mg every 8 hours)
Pattern: | Hepatocellular (R=15.4)
Severity: | 5+ (death)
Latency: | 10 days
Recovery: | No
Other medications: | Zidovudine, co-trimoxazole, nortriptyline, fluconazole, doxepin

#### Laboratory Values

Time After Starting | Time After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
0 | 0 | 28 | 99 | 0.5
10 days | 0 | 690 | 145 | 17.4
5 weeks | 4 weeks | - | - | - | Death
Normal Values | | <40 | <130 | <1.2

#### Comment

Despite this case being considered evidence of indinavir hepatotoxicity, there are many other possibilities. Immune reconstitution with a severe flare of the underlying chronic hepatitis B is possible, although 10 days is quite rapid for this process, which generally occurs as CD4 counts rise and is accompanied by a rise and then fall in HBV DNA levels. Another possibility is lactic acidosis and hepatic failure due to mitochondrial injury caused by the zidovudine therapy, perhaps augmented by the recent addition of indinavir. Finally, fluconazole and trimethoprim sulfamethoxazole are both capable of causing an acute severe hepatitis that can be fatal; without information on the duration of therapy with these agents it is difficult to discount this possibility. Regardless of the mechanism, however, the addition of indinavir 10 days before the onset of symptoms suggests that it was responsible at least in part for the sudden appearance of acute liver failure.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Indinavir – Crixivan®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Indinavir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Indinavir | 157810-81-6 | C36-H47-N5-O4.H2-O4-S | Indinavir Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Indinavir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Indinavir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Indinavir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Indinavir)